# Ginseng

## OVERVIEW

### Introduction

Ginseng is a popular herbal medication and extract derived from the roots of a perennial plant (Panax ginseng) found mostly in China, Korea and Siberia. Ginseng is used is to promote health and improve wellness, as well as to treat stress and as a mild stimulant. Ginseng has not been implicated in causing liver injury although it may have the potential of causing significant herb-drug interactions that can lead to liver injury.

### Background

Ginseng (jin' seng) is a widely used herbal derived from the roots of eleven distinct species of plants belonging to the genus Panax and family Araliaceae. Ginseng grows in the Northern Hemisphere in eastern Asia, mostly China, Korea and Siberia. The form of ginseng most commonly used is Asian (or Chinese) ginseng made from the dried roots of Panax ginseng. American ginseng (Panax quinquefolius) has similar properties. The word ginseng derives from the Chinese character “rénshen” meaning “man root”, which refers to the ginseng root’s characteristic forked shape. The botanical name Panax is derived from the Greek word meaning “all-heal” as in the term panacea. Ginseng is taken promote health and healing, as an adaptogen (to treat stress and enhance recovery from illness), aphrodisiac (to aid in sexual desire and performance) and a stimulant (wakefulness and mental acuity). Ginseng is also claimed to lower blood glucose levels and to be beneficial in diabetes. Ginseng is found in energy drinks as well as in many cosmetic preparations. The scientific bases for the purported effects of ginseng are not well established. Ginseng contains 30 different triterpene saponins, referred to as ginsenosides and panaxosides, which are considered the active compounds and which have antioxidant and stimulatory activities. Commercial preparations of ginseng vary widely in ginsenoside content (some have none at all), which may cause variation in their biologic effects. The recommended daily dose varies widely (100 to >1,000 mg daily), depending on the preparation used (capsules, tablets, liquid, root extract, tea) and indications. Side effects of ginseng are uncommon and mild, and include inability to sleep, nausea, morning diarrhea, headaches and nose bleeds.

### Hepatotoxicity

Despite wide spread use, ginseng by itself has not been linked to liver injury, either in the form of transient serum enzyme elevations or clinically apparent acute liver injury. Indeed, ginseng is sometimes used to treat acute or chronic liver injury, although its efficacy and safety in this situation have not been proven. Nevertheless, ginseng has been reported to affect cytochrome P450 activity and cause significant herb-drug interactions that can lead to adverse events including liver injury. In vitro studies have found that different gensinosides have different effects on cytochrome P450 activity, and some may inhibit CYP 3A4 sufficiently to affect the metabolism of other drugs, increasing or decreasing their activity. Thus, different ginseng preparations may exhibit varying degrees of herb-drug interaction. Liver injury has been reported to develop 1 to 3 months after starting ginseng in patients who previously tolerated the potentially toxic agent (imatinib, raltegravir) without liver injury and who later tolerated restarting the medication without concurrent ginseng use.

Likelihood score: E (by itself, unlikely cause of clinically apparent liver injury).

Drug Class: Herbal and Dietary Supplements

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Ginseng – Generic

DRUG CLASS

Herbal and Dietary Supplements

SUMMARY INFORMATION

(Ginseng, American) Fact Sheet at MedlinePlus, NLM (http://www.nlm.nih.gov/medlineplus/druginfo/natural/967.html)

(Ginseng, Siberian) Fact Sheet at MedlinePlus, NLM (http://www.nlm.nih.gov/medlineplus/druginfo/natural/985.html)

(Ginseng, Asian or N. American) Fact Sheet at National Center for Complementary and Integrative Health, NIH (https://nccih.nih.gov/health/asianginseng)

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Ginseng | 50647-08-0 | Herbal mixture | Not applicable

## ANNOTATED BIBLIOGRAPHY

References updated: 14 March 2018

Zimmerman HJ. Unconventional drugs. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott,1999: pp. 731-4. (Expert review of hepatotoxicity published in 1999; ginseng is not discussed).
Seeff L, Stickel F, Navarro VJ. Hepatotoxicity of herbals and dietary supplements. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 631-58. (Review of hepatotoxicity of herbal and dietary supplements [HDS]; ginseng is not discussed).
Ginseng. In, PDR for Herbal Medicines. 4th ed. Montvale, New Jersey: Thomson Healthcare Inc. 2007: pp. 384-92. (Compilation of short monographs on herbal medications and dietary supplements).
Cui J, Garle M, Eneroth P, Bjorkhem I. (1994). What do commercial ginseng preparations contain?. Lancet. (Analysis of 50 commercial ginseng products sold in 11 countries found concentration of ginsenosides varied from 1.9-9%, and 6 [12%] had none and were likely not made from ginseng).
Janetzky K, Morreale AP. (1997). Probable interaction between warfarin and ginseng. Am J Health Syst Pharm. (47 year old man on anticoagulation for a mechanical heart valve with INR maintained between 3.0 and 4.0 started ginseng capsules three times daily and, two weeks later, INR was 1.5, returning to previous level upon stopping ginseng).
Vogler BK, Pittler MH, Ernst E. (1999). The efficacy of ginseng. A systematic review of randomised clinical trials. Eur J Clin Pharmacol. (Systematic review of the literature found 16 trials of ginseng root extract, but found that evidence for benefit was not compelling for any indication: physical and psychomotor performance, cognitive function, diabetes and herpes simplex).
Kitts D, Hu C. (2000). Efficacy and safety of ginseng. Public Health Nutr. (Review of the history, composition, purported effects, clinical efficacy and safety of ginseng).
Stedman C. (2002). Herbal hepatotoxicity. Semin Liver Dis. (Review and description of patterns of liver injury, including discussion of potential risk factors, and herb-drug interactions; ginseng may interact with warfarin causing a decrease in anticoagulation).
De Smet PAGM. (2002). Herbal remedies. N Engl J Med. (Review of status and difficulties of herbal medications including lack of standardization, federal regulation, contamination, safety, hepatotoxicity and drug-herb interactions; specific discussion of 4 herbs with therapeutic promise: ginkgo, hawthorn, saw palmetto and St. John’s wort).
Schiano TD. (2003). Hepatotoxicity and complementary and alternative medicines. Clin Liver Dis. (Comprehensive review of herbal associated hepatotoxicity; ginseng is not listed as causing hepatotoxicity).
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. (2004). Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl. (Among ~50,000 liver transplants reported to UNOS between 1990 and 2002, 270 [0.5%] were done for drug induced acute liver failure, including 7 [5%] for herbal medications, none attributed to ginseng use).
García-Cortés M, Borraz Y, Lucena MI, Peláez G, Salmerón J, Diago M, Martínez-Sierra MC, et al. (2008). Rev Esp Enferm Dig. (Among 521 cases of drug induced liver injury submitted to a Spanish registry, 13 [2%] were due to herbals, but none were attributed to ginseng).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, 9% of cases were attributed to herbal medications, but none were linked to ginseng use).
Saxena A, Tripathi KP, Roy S, Khan F, Sharma A. (2008). Pharmacovigilance: effects of herbal components on human drugs interactions involving cytochrome P450. Bioinformation. (Review of effects of St. John's wort, piperine, ginsenosides and ginkgolic acid on cytochrome P450 activity; in vitro ginsenosides have inhibitory activity against CYP 2E1 and CYP 3A4).
Hao M, Zhao Y, Chen P, Huang H, Liu H, Jiang H, Zhang R, Wang H. (2008). Structure-activity relationship and substrate-dependent phenomena in effects of ginsenosides on activities of drug-metabolizing P450 enzymes. PLoS One. (Ginsenosides with different structures have different effects on cytochrome P450 activity).
Navarro VJ. (2009). Herbal and dietary supplement hepatotoxicity. Semin Liver Dis. (Overview of the regulatory environment, clinical patterns, and future directions in research with HDS; ginseng is not listed as a potentially hepatotoxic botanical).
Jacobsson I, Jönsson AK, Gerdén B, Hägg S. (2009). Spontaneously reported adverse reactions in association with complementary and alternative medicine substances in Sweden. Pharmacoepidemiol Drug Saf. (Review of 778 spontaneous reports of adverse reactions to herbals to Swedish Registry found 14 [2%] attributed to ginseng, including 2 with a "mixed liver reaction" and 2 with enzyme elevations, but no details given).
Bilgi N, Bell K, Ananthakrishnan AN, Atallah E. (2010). Imatinib and Panax ginseng: a potential interaction resulting in liver toxicity. Ann Pharmacother. (26 year old man with CML on imatinib for 7 years developed symptomatic liver injury 3 months after starting daily use of an energy drink with Panax ginseng [bilirubin 1.4 mg/dL, ALT 1069 U/L, Alk P 124 U/L] which resolved with stopping both medications, but he was able to restart imatinib without recurrence of liver injury after recovery and while remaining off of ginseng).
Mateo-Carrasco H, Gálvez-Contreras MC, Fernández-Ginés FD, Nguyen TV. (2012). Elevated liver enzymes resulting from an interaction between Raltegravir and Panax ginseng: a case report and brief review. Drug Metabol Drug Interact. (Abstract only: Patient with chronic hepatitis C and HIV infection on long term antiretroviral therapy with raltegravir, lopinavir and ritonavir developed jaundice 39 days after starting ginseng tablets, resolving with stopping herbal intake ).
Bunchorntavakul C, Reddy KR. (2013). Review article: herbal and dietary supplement hepatotoxicity. Aliment Pharmacol Ther. (Systematic review of literature on HDS associated liver injury mentions that ginseng can have significant herb-drug interactions).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, including 15 [16%] due to herbal and dietary supplements, but none were attributed to ginseng containing products).
Dağ MS, Aydınlı M, Oztürk ZA, Türkbeyler IH, Koruk I, Savaş MC, Koruk M, et al. (2014). Drug- and herb-induced liver injury: a case series from a single center. Turk J Gastroenterol. (Between 2008 and 2012, 82 patients with drug or herbal supplement induced liver injury were seen at a single referral center in Turkey, 10 [12%] of which were due to HDS products, including 7 due to Teucrium polium [mountain germander] and 3 to green tea extract, but none to ginseng).
Navarro VJ, Barnhart H, Bonkovsky HL, Davern T, Fontana RJ, Grant L, Reddy KR, et al. (2014). Liver injury from herbals and dietary supplements in the U.S. Drug-Induced Liver Injury Network. Hepatology. (Among 85 cases of HDS associated liver injury [not due to anabolic steroids] enrolled in a US prospective study between 2004 and 2013, none were attributed to a known ginseng containing product).
Seeff LB, Bonkovsky HL, Navarro VJ, Wang G. (2015). Herbal products and the liver: a review of adverse effects and mechanisms. Gastroenterology. (Extensive review of possible beneficial as well as harmful effects of herbal products on the liver mentions that there have been numerous reports of liver injury from germander).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a prospective database between 2004 and 2012, HDS were implicated in 145 [16%], none of which were primarily attributed to germander: see Navarro [2014]).
García-Cortés M, Robles-Díaz M, Ortega-Alonso A, Medina-Caliz I, Andrade RJ. (2016). Hepatotoxicity by Dietary Supplements: A tabular listing and clinical characteristics. Int J Mol Sci. (Listing of published cases of liver injury from HDS products does not discuss ginseng in the listings]).
Avigan MI, Mozersky RP, Seeff LB. (2016). Scientific and regulatory perspectives in herbal and dietary supplement associated hepatotoxicity in the United States. Int J Mol Sci. (Overview of the US regulations regarding herbal and dietary supplements and role of FDA, Department of Agriculture, Federal Trade Commission and Office of Dietary Supplements of the NIH in assessment of safety of HDS products including actions taken against commercial products when reports of liver injury appeared in postmarketing phase).
Kim TW. (2016). Ginseng for Liver Injury: Friend or Foe?. Medicines (Basel). (Review of literature on hepatoprotective and hepatotoxic effects of ginseng which is active in decreasing hepatic injury in several animal models of liver disease and which is largely safe although has important drug-herb interactions because of inhibition of CYP 3A4 activity which can raise levels of other medications that are more hepatotoxic at higher doses).
Dong H, Ma J, Li T, Xiao Y, Zheng N, Liu J, Gao Y, et al. (2017). Global deregulation of ginseng products may be a safety hazard to warfarin takers: solid evidence of ginseng-warfarin interaction. Sci Rep. (Studies in rats demonstrate that purified ginseng extracts increase CYP 3A4 activity and inhibit the effects of warfarin on coagulation factors, suggesting that use of ginseng may cause reversal of warfarin's protective effects against thomboembolic events).
Myers AP, Watson TA, Strock SB. (2015). Drug reaction with eosinophilia and systemic symptoms syndrome probably induced by a lamotrigine-ginseng drug interaction. Pharmacotherapy. (44 year old man developed rash and eosinophilia 35 days after starting lamotrigine for seizures and while taking ginseng daily for general health [bilirubin 1.4 mg/dL, ALT 473 U/L, Alk P 465 U/L, eosinophils 3040/µL], resolving within 3 weeks of stopping lamotrigine).
Brown AC. An overview of herb and dietary supplement efficacy, safety and government regulations in the United States with suggested improvements. Part 1 of 5 series. Food Chem Toxicol 2017; 107(Pt A): 449-71. (Summary of the US regulations on safety and efficacy of herbal and dietary supplements).
Brown AC. Liver toxicity related to herbs and dietary supplements: Online table of case reports. Part 2 of 5 series. Food Chem Toxicol 2017; 107(Pt A): 472-501. (Description of an online compendium of cases of liver toxicity attributed to HDS products, mentions that germander was the most frequently implicated herb in causing liver injury listing 23 references of single case reports and case series).
Wong LL, Lacar L, Roytman M, Orloff SL. (2017). Urgent liver transplantation for dietary supplements: an under-recognized problem. Transplant Proc. (Among 2048 adult liver transplants recipients enrolled in the Scientific Registry of Transplant Recipients [SRTR] between 2003 and 2015, 625 were done for acute hepatic necrosis due to drug induced liver injury, half being due to acetaminophen and the 4th most frequent cause [n=21] being HDS products, but ginseng was not implicated in any case).
de Boer YS, Sherker AH. (2017). Herbal and dietary supplement-induced liver injury. Clin Liver Dis. (Review of the frequency, clinical features, patterns of injury and outcomes of HDS hepatotoxicity with specific mention of anabolic steroids, black cohosh, germander, green tea, pyrrolizidine alkaloids and proprietary multiingredint nutrition supplements [MINS]).
Vega M, Verma M, Beswick D, Bey S, Hossack J, Merriman N, Shah A, et al., Drug Induced Liver Injury Network (DILIN). (2017). The incidence of drug- and herbal and dietary supplement-induced liver injury: preliminary findings from gastroenterologist-based surveillance in the population of the State of Delaware. Drug Saf. (A prospective, population based registry of cases of drug induced liver injury occurring in Delaware during 2014, identified 20 cases [2.7 per 100,000] overall, including 6 due to HDS products, all of which were proprietary multiingredient products, none specifically mentioning ginseng).

## OTHER REFERENCE LINKS

1 Recent References on Ginseng: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Ginseng+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Ginseng: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Ginseng)